# Alprazolam

## OVERVIEW

### Introduction

Alprazolam is an orally available benzodiazepine used predominantly for therapy of anxiety. As with most benzodiazepines, alprazolam t has not been associated with serum aminotransferase or alkaline phosphatase elevations during therapy, and clinically apparent liver injury from alprazolam has been reported but is very rare.

### Background

Alprazolam (al pra' zoe lam) is a benzodiazepine that is widely used in the therapy of anxiety and panic disorder. The antianxiety (anxiolytic) activity of the benzodiazepines is mediated by their ability to enhance gamma-aminobutyric acid (GABA) mediated inhibition of synaptic transmission through binding to the GABA A receptor. Alprazolam was approved in the United States in 1981, and is currently the most commonly used oral benzodiazepine, with more than 16 million prescriptions filled yearly. Current indications are for anxiety and panic disorders. Alprazolam is available in multiple generic forms and under several brand names such as Xanax and Niravam in tablets of 0.25, 0.5, 1 and 2 mg, as well as in orally disintegrating tablets in similar concentrations and as an oral solution [1 mg/mL] for pediatric use. Extended release forms are available in tablets of 0.25, 0.5, 1, and 2 mg. The recommended initial dose for adults is 0.5 mg three times daily, increasing as needed to a maximum dose of 4 mg daily in divided doses. Higher doses are used for panic disorder. The most common side effects of alprazolam are dose related and include drowsiness, lethargy, ataxia, dysarthria and dizziness. Tolerance develops to these side effects, but tolerance may also develop to the anxiolytic effects. Alprazolam like all oral benzodiazepines has a boxed warning in its product label stressing (1) the risks of severe sedation and potentially fatal respiratory depression when combined with opiates, (2) with prolonged use, the risks of abuse, misuse, and addiction which can lead to overdose and death, and (3) with continued use, the risks of physical and psychological dependence and severe potentially life-threatening withdrawal symptoms if discontinued suddenly. Benzodiazepines are all categorized as Schedule IV controlled substances, having potential for dependence, tolerance, and abuse.

### Hepatotoxicity

Alprazolam, like other benzodiazepines, is rarely associated with serum ALT or alkaline phosphatase elevations, and clinically apparent liver injury from alprazolam is extremely rare, considering the frequency of its use. There have been a few case reports of acute liver injury from alprazolam, and recurrence on reexposure has been reported. In alprazolam-related cases of acute liver injury, the latency has been within a few weeks and the typical pattern of liver enzyme elevations has been cholestatic or mixed (Case 1). The injury was usually mild-to-moderate in severity and self-limited in course. Fever and rash have not been described nor has autoantibody formation. Similar rare cases of self-limited, mild-to-moderate, cholestatic liver injury have been reported with other benzodiazepines including chlordiazepoxide, clonazepam, diazepam, flurazepam, lorazepam, and triazolam.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

Alprazolam is metabolized by the liver via the cytochrome P450 system, predominantly by CYP 3A4. Concurrent use of CYP 3A4 inhibitors, such as cimetidine or ketaconazole, can cause an increase in alprazolam plasma levels. The liver injury from the benzodiazepines is probably due to a rarely produced intermediate metabolite.

### Outcome and Management

The case reports of hepatic injury due to benzodiazepines were followed by prompt and complete recovery upon stopping the medication, without evidence of residual or chronic injury. No cases of acute liver failure or chronic liver injury due to alprazolam have been described. There is little information about cross reactivity with other benzodiazepines, but some degree of cross sensitivity should be assumed, and patients with clinically apparent liver injury due to alprazolam should be monitored if they are switched to related agents.

Drug Class: Benzodiazepines, Antianxiety Agents

## CASE REPORT

### Case 1. Mild acute liver injury due to alprazolam.(1)

A 32 year old woman with a long history of panic attacks developed fatigue and abdominal pain 2 weeks after starting alprazolam (1 mg daily increasing to 8 mg daily), and she became jaundiced one week later. She had no history of liver disease and was known to have had normal serum liver tests before starting alprazolam. On examination, she was jaundiced but had no fever or rash. Laboratory results showed elevations in serum enzymes and bilirubin (Table). Tests for hepatitis A and B and for mononucleosis were negative. Alprazolam was stopped and diazepam (which she had received in the past) substituted. She improved rapidly and all tests were normal when she was seen one month after stopping alprazolam.

### Key Points

Medication: | Alprazolam (8 mg daily)
Pattern: | Cholestatic (R=1.8)
Severity: | 2+ (jaundiced)
Latency: | 2 weeks to symptoms, 3 weeks to jaundice
Recovery: | Complete in one month
Other medications: | None mentioned

### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | | Normal | Normal | Normal
3 weeks | 0 | 156 | 241 | 2.6 | Albumin 4.0 g/dL
| 4 days | 124 | 187 | 1.8
7 weeks | 4 weeks | Normal | Normal | Normal
Normal Values | | <35 | <95 | <1.2

### Comment

A convincing case of alprazolam induced liver injury characterized by a mild cholestatic hepatitis arising 2 to 3 weeks after starting the medication and resolving rapidly with stopping. There were no signs of hypersensitivity. Interestingly, she tolerated other benzodiazepines without problems, indicating lack of cross sensitivity to the injury.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Alprazolam – Generic, Niravam®, Xanax®

DRUG CLASS

Benzodiazepines

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Alprazolam)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Alprazolam | 28981-97-7 | C17-H13-Cl-N4

## CITED REFERENCES

1 Judd FK, Norman TR, Marriott PF, Burrows GD. (1986). A case of alprazolam-related hepatitis. Am J Psychiatry.

## ANNOTATED BIBLIOGRAPHY

References updated: 22 June 2023

Zimmerman HJ. Benzodiazepines. Psychotropic and anticonvulsant agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 491-3. (Expert review of benzodiazepines and liver injury published in 1999; mentions rare instances of cholestatic hepatitis have been reported due to alprazolam, chlordiazepoxide, diazepam, flurazepam, and triazolam, and hepatocellular injury with clorazepate and clotiazepam, but no reports of hepatic injury with lorazepam, oxazepam or temazepam).
Larrey D, Ripault MP. Anxiolytic agents. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 455. (Review of sedative induced liver injury mentions that rare instances of acute liver injury [usually cholestatic] have been reported with alprazolam, bentazepam, clotiazepam, chlordiazepoxide, diazepam, flurazepam and triazolam; a hepatitis-like pattern has been reported with clonazepam and clorazepate).
Mihic SJ, Mayfield J, Harris RA. Hypnotics and sedatives. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 339-53. (Textbook of pharmacology and therapeutics).
Roy-Byrne P, Vittone BJ, Uhde TW. (1983). Alprazolam-related hepatotoxicity. Lancet. (Patient was found to have elevated ALT [96 U/L] 2 weeks after starting alprazolam, with prompt resolution upon stopping; rechallenge led to asymptomatic rise of ALT [28 to 70 U/L] within 9 days).
Davion T, Capron-Chivrac D, Andrejak M, Capron JP. (1985). Gastroenterol Clin Biol. (Review of hepatotoxicity of anticonvulsants; among benzodiazepines, cases of cholestatic hepatitis have been linked to chlordiazepoxide and diazepam, but liver injury from this class of drugs is exceptionally rare).
Judd FK, Norman TR, Marriott PF, Burrows GD. (1986). A case of alprazolam-related hepatitis. Am J Psychiatry. (32 year old woman had onset of lethargy 2 weeks after starting alprazolam followed by jaundice [bilirubin 2.6 mg/dL, AST 156 U/L, Alk P 241 U/L], resolving within 4 weeks of switching to diazepam: Case 1).
Noyes R, DuPont RL, Pecknold JC, Rifkin A, Rubin RT, Swinson RP, Ballenger JC, et al. (1988). Alprazolam in panic disorder and agoraphobia: results from a multicenter trial. Arch Gen Psychiatry. (Controlled trial of alprazolam vs placebo in 525 patients with panic disorder; side effects were sedation, ataxia, fatigue, slurred speech, amnesia, and increased appetite; 2 patients on alprazolam developed liver disease, one with jaundice at 4 weeks resolving quickly on stopping and a second with abnormal laboratory values that returned to normal with lowering the dose; details not given).
Lewis JH, Zimmerman HJ. (1999). Drug- and chemical-induced cholestasis. Clin Liver Dis. (Review of drug induced cholestatic syndromes, listing many causes including chlordiazepoxide and flurazepam; “Benzodiazepines may cause cholestatic injury, although this is rare”).
Gil-Martín A, Sáez-Royuela F, Arias L, Angulo ML, Nogal B. (2005). Rev Esp Enferm Dig. (Case report of patient developing fatigue, pruritus and jaundice after 1-2 months of therapy with sertraline, alprazolam and clorazepate, resolving with stopping sertraline, but with minor ALT elevations and biopsy showing mild bridging fibrosis 4 months later).
Sabaté M, Ibáñez L, Pérez E, Vidal X, Buti M, Xiol X, Mas A, et al. (2007). Risk of acute liver injury associated with the use of drugs: a multicentre population survey. Aliment Pharmacol Ther. (Among 126 cases of drug induced liver injury seen in Spain between 1993-2000, 20 were attributed to benzodiazepines including 5 for clorazepate, 5 alprazolam, 6 lorazepam and 4 diazepam, but compared to controls, the relative risk of injury was increased only for clorazepate [8.3 and frequency 3.4 per 100,000 person-year exposures]).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, none were attributed to a benzodiazepine).
Björnsson E. (2008). Hepatotoxicity associated with antiepileptic drugs. Acta Neurol Scand. (Review of hepatotoxicity of all anticonvulsants focusing upon phenytoin, valproate, carbamazepine; “Furthermore, hepatoxicity has not been convincingly shown to be associated with the use of benzodiazepines”).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to a benzodiazepine).
(2012). Drugs for insomnia. Treat Guidel Med Lett. (Guidelines for therapy of insomnia mentions that benzodiazepines are controlled substances and, when used for sleep, may impair next day performance).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population-based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to alprazolam or any other benzodiazepine, despite the fact that more than 1 million prescriptions for alprazolam are filled yearly).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature on drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were attributed to a benzodiazepine).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, no cases were attributed to alprazolam or any other benzodiazepine).
(2019). Drugs for anxiety disorders. Med Lett Drugs Ther. (Concise review of drugs for anxiety including benzodiazepines summaries mechanism of action, clinical efficacy, safety, and costs; comments that benzodiazepines such as alprazolam can provide immediate relief of anxiety symptoms, but long term therapy can cause tolerance and dependence, and sudden withdrawal can cause severe and even life-threatening symptoms; no mention of ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Alprazolam: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Alprazolam/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Alprazolam: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Alprazolam)